# Cabotegravir

## OVERVIEW

### Introduction

Cabotegravir is an antiviral agent that inhibits the human immunodeficiency virus (HIV) integrase and is used in combination with rilpivirine, a non-nucleoside HIV reverse transcription inhibitor, in the treatment of HIV infection and the acquired immunodeficiency syndrome (AIDS). The fixed combination of cabotegravir and rilpivirine is typically given intramuscularly once monthly and has been linked to a low rate of serum aminotransferase elevations during therapy and to rare episodes of acute, clinically apparent liver injury.

### Background

Cabotegravir (ka” boe teg’ ra vir) is an antiretroviral drug that targets the HIV integrase, one of the three critical viral enzymes involved in HIV replication. Cabotegravir binds to the catalytic site of the HIV integrase, preventing the strand transfer activity and integration of the provirus into the host genome. Cabotegravir has both in vitro and in vivo activity against HIV and was developed as both oral and parenterally administered forms. In several randomized controlled trials, injections of a long acting formulation of cabotegravir in a fixed combination with a long acting rilpivirine, a non-nucleoside HIV reverse transcriptase inhibitor, at 4 or 8 week intervals was found to effectively replace stable, effective daily oral regimens for HIV infection. Cabotegravir was approved as therapy of HIV infection in the United States in 2021, but only in combination with rilpivirine in both tablet (oral) forms as a 4 week lead-in therapy to parenteral therapy with solutions of long acting cabotegravir and rilpivirine given by intramuscular injections every 4 or 8 weeks for long term maintenance therapy. The fixed combination of cabotegravir and rilpivirine was initially indicated only for patients with HIV infection on an oral antiviral regimen that effectively suppressed viral levels to less than 50 copies/mL. The oral forms of cabotegravir and rilpivirine were approved only as lead-in to starting the monthly parenteral administration (or as temporary therapy of patients who miss a monthly injection). The long acting formulation of cabotegravir was approved for use as monotherapy in 2022 as a means of preventing HIV infection in high risk individuals. Cabotegravir is available in tablets of 30 mg under the brand name Vocabria to be used in combination with rilpivirine in tablets of 25 mg for one month before initiating parenteral injections. Cabotegravir and rilpivirine are also available in solution for intramuscular injection as a fixed combination of 400 and 600 mg for every 4 week administration and 600 and 900 mg for every 8 week administration under the brand name Cabenuva. Clinical trials have more recently shown that the combination of cabotegravir and rilpivirine can be used as an initial means of treating HIV infection without an oral lead-in phase. Finally, the long acting formulation of cabotegravir in solution is available separately for prevention of HIV infection in high risk individuals under the brand name Apretude. Common side effects of cabotegravir include headache, nausea, insomnia, vivid dreams, and anxiety, as well as injection site reactions with parenteral regimens. Less common but potentially severe adverse events include hypersensitivity reactions (fever, rash, angioedema, conjunctivitis, blisters and oral ulcers, DRESS syndrome), hepatotoxicity, and depression.

### Hepatotoxicity

In large clinical trials, switching antiretroviral therapy of HIV infection to the combination of parenteral injections of long acting cabotegravir and rilpivirine was associated with alanine aminotransferase (ALT) elevations in up to 7% of patients, but levels above 5 times the upper limit of normal (ULN) arose in only 1% to 2% of subjects. The elevations were typically transient, asymptomatic, and rarely required dose modification or discontinuation. While clinically apparent liver injury with jaundice was reported to occur in early studies, there were no such cases in the large, preregistration trials of long acting, parenteral cabotegravir and rilpivirine used for treatment of HIV infection or in the large trials of long acting cabotegravir used as prophylaxis against acquiring HIV infection. The use of injections every 4 or 8 weeks has been found to improve compliance and to be preferable to daily oral therapy by many patients requiring long term antiretroviral therapy. Since approval of cabotegravir for use as maintenance therapy and for prophylaxis against HIV infection, there have been no case reports of clinically apparent hepatotoxicity associated with its use.

Interestingly, in the large preregistration trials of parenteral cabotegravir and rilpivirine as replacement therapy of HIV infection, cases of acute hepatitis A, B and C were reported as adverse events, occurring largely in patients who had been switched to the parenteral regimen compared to control subjects who were continued on oral agents. The reasons for these differences were unclear. Importantly, neither cabotegravir or rilpivirine have activity against hepatitis B virus (HBV), and one possibility has been that reactivation of hepatitis B may occur after withdrawal of oral antiretroviral agents that have activity against HBV, such as tenofovir, emtricitabine, and lamivudine. For this reason, patients starting long- acting parenteral regimens of cabotegravir and rilpivirine should be screened for hepatitis B virus markers and potential risks of stopping agents with activity against HBV should be considered. In addition, persons with HIV without protective antibodies to HAV and HBV should be offered hepatitis A and B virus vaccination.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

Cabotegravir is metabolized by the liver and undergoes glucuronidation as a part of its metabolic clearance. It does not have an effect on the CYP 450 system. Concomitant use of potent inducers of UGT1A can result in lower plasma levels which can predispose to virologic failure and development of antiviral resistance.

### Outcome and Management

Serum enzyme elevations during combination therapy with cabotegravir and rilpivirine are not uncommon but are generally transient, mild-to-moderate in severity, and often attributable to other causes. Nevertheless, aminotransferase elevations above 5 times the ULN, if confirmed, warrant dose interruption and evaluation for other causes of acute liver injury. Because cabotegravir is usually given in combination with rilpivirine, it is difficult to attribute the injury to a single agent, and the combination generally needs to be discontinued if the injury is persistent or associated with symptoms or jaundice. HIV integrase inhibitors have rarely been implicated in causing hepatotoxicity and there is no information about the cross sensitivity to liver injury among the various HIV integrase inhibitors.

Drug Class: Antiviral Agents

Other Drugs in the Subclass, Integrase Strand Transfer Inhibitors: Bictegravir, Dolutegravir, Elvitegravir, Raltegravir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cabotegravir – Cabenuva®, Apretude®, Vocabria®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Cabotegravir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cabotegravir | 1051375-10-0 | C19-H17-F2-N3-O5
Rilpivirine | 500287-72-9 | C22-H18-N6

## ANNOTATED BIBLIOGRAPHY

References updated: 17 June 2023

Abbreviations: HIV, human immunodeficiency virus; im, intramuscular.

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents including raltegravir but not cabotegravir).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Hillal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1137-57. (Textbook of pharmacology and therapeutics).
https://hivinfo.nih.gov/hiv-source/medical-practice-guidelines/hiv-treatment-guidelines (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/212887Orig1s000,212888Orig1s000IntegratedR.pdf (FDA website with product labels and the integrated review of the data submitted in support of its approval, mentions that liver injury suspected to be drug induced arose in early phase 2 trials of cabotegravir but there were no cases in the large-scale, phase 3 registration trials; however, there were multiple cases of acute hepatitis A, B and C that were not identified in control groups, some of which may have related to withdrawal of antiretroviral agents with activity against HBV since cabotegravir and rilpivirine have no activity against hepatitis B, furthermore patients with HIV infection should be given both hepatitis A and B vaccines as these are preventable diseases).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were due to antiretroviral agents, but none were attributed to cabotegravir or other HIV integrase inhibitors).
Margolis DA, Gonzalez-Garcia J, Stellbrink HJ, Eron JJ, Yazdanpanah Y, Podzamczer D, Lutz T, et al. (2017). Long-acting intramuscular cabotegravir and rilpivirine in adults with HIV-1 infection (LATTE-2): 96-week results of a randomised, open-label, phase 2b, non-inferiority trial. Lancet. (Among 309 treatment naïve adults with HIV infection who were treated with oral cabotegravir [30 mg once daily], lamivudine and abacavir for 20 weeks, 286 had a virologic response [HIV RNA <50 copies/mL] and were randomized to continue oral therapy or switch to long acting intramuscular [im] cabotegravir and rilpivirine every 4 weeks [400 mg and 600 mg] or every 8 weeks [600 mg or 900 mg] and followed for up to 96 weeks, during which the 3 treatment arms had similar rates of virologic response maintenance and similar rates of adverse events except for injection site reactions with the im regimens; ALT elevations above 5 times ULN arose in 3% on im regimens and 5% on oral regimens mostly due to hepatitis C infection, but two patients on the oral regimen were judged to have probable drug induced liver injury which resolved with stopping therapy [no details provided]).
Kolakowska A, Maresca AF, Collins IJ, Cailhol J. (2019). Update on adverse effects of HIV integrase inhibitors. Curr Treat Options Infect Dis. (Review of the adverse events with HIV integrase inhibitors including dolute-, ralte-, bicte- and elvite-gravir mentions that there is little evidence that this class of antiretrovirals causes elevations in serum aminotransferase or alkaline phosphatase levels, but that data on the safety and efficacy of cabotegravir are promising but still incomplete).
Swindells S, Andrade-Villanueva JF, Richmond GJ, Rizzardini G, Baumgarten A, Masiá M, Latiff G, et al. (2020). Long-acting cabotegravir and rilpivirine for maintenance of HIV-1 suppression. N Engl J Med. (Among 616 adults with HIV infection and maintained suppression of HIV RNA [less than 50 copies/mL] on oral antiretroviral therapy, who were either continued on oral therapy or switched to monthly injections of long acting cabotegravir and rilpivirine, effective suppression was maintained in 95.5% on oral therapy vs 92.5% or long acting parenteral therapy, while adverse event rates were similar except for injection site reactions [none vs 81%], while acute viral hepatitis [A, B and C] was identified as an adverse event in 1 case on oral and 4 on parenteral therapy [0.3% vs 1.3%]).
Orkin C, Arasteh K, Górgolas Hernández-Mora M, Pokrovsky V, Overton ET, Girard PM, Oka S, et al. (2020). Long-acting cabotegravir and rilpivirine after oral induction for HIV-1 infection. N Engl J Med. (Among 566 adults with previously untreated HIV infection with a virologic response [HIV RNA less than 50 copies/mL] to a 20-week induction regimen of dolutegravir, abacavir, and lamivudine who were then continued on oral therapy or switched to once-monthly injections with long acting cabotegravir and rilpivirine, maintenance of a virologic response was similar in the two groups [93.3% vs 93.6%] while adverse event rates were similar except for injection site reactions [none vs 80%] and acute hepatitis A, B, or C [1 vs 7 cases: 0.3% vs 2.5%]).
Currier JS. (2020). Monthly injectable antiretroviral therapy – version 1.0 of a new treatment approach. N Engl J Med. (Editorial accompanying publications of Swindells and Orkin [2020] discussing the promise of a once monthly or bimonthly therapy for HIV infection).
(2021). Cabotegravir/rilpivirine (Cabenuva) for HIV-1 infection. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of the fixed combination of cabotegravir and rilpivirine given orally for one month and then as monthly injections for long term management of HIV infection).
Landovitz RJ, Donnell D, Clement ME, Hanscom B, Cottle L, Coelho L, Cabello R, et al., HPTN 083 Study Team. (2021). Cabotegravir for HIV prevention in cisgender men and transgender women. N Engl J Med. (Among 4566 adults at high risk of acquiring HIV infection given prophylaxis with oral tenofovir and emtricitabine daily or intramuscular cabotegravir [600 mg a baseline, week 4 and 9 and then every 8 weeks], incident HIV arose in 39 on oral prophylaxis [1.22 per 100-person years] vs 13 on cabotegravir infections [0.41 per 100-person years], while both total and serious adverse event rates were similar in the two groups with ALT elevations in 8.4% vs 7.0% which were above 3 times ULN in 1.0% vs 1.2%).
Delany-Moretlwe S, Hughes JP, Bock P, Ouma SG, Hunidzarira P, Kalonji D, Kayange N, et al., HPTN 084 study group. (2022). Cabotegravir for the prevention of HIV-1 in women: results from HPTN 084, a phase 3, randomised clinical trial. Lancet. (Among 3224 sexually active, Subsaharan African women, ages 18 to 45, treated with oral tenofovir and emtricitabine daily or intramuscular cabotegravir [600 mg at baseline, week 4 and every 8 weeks thereafter], incident HIV arose in 36 on oral prophylaxis vs 4 on injected cabotegravir [1.85 vs 0.2 per 100 person-years], while adverse events, except for injection site reactions, were similar in the two groups; 2 subjects on oral prophylaxis but none on cabotegravir developed serious hepatic adverse events).
(2022). Cabotegravir (Apretude) for HIV-1 pre-exposure prophylaxis. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy, side effects, and costs of long acting, parenterally administered cabotegravir shortly after its approval an preventive therapy of HIV infection, mentions that hypersensitivity reactions, hepatotoxicity, and depressive disorders have been reported with cabotegravir therapy).
Sutton KC, De Vente J, Leblanc R, Dejesus E, Smith G, Mills A, Baril JG, et al. Long-term efficacy, safety, and durability of cabotegravir and rilpivirine as 2-drug oral maintenance therapy after 6 years of study. Open Forum Infect Dis. 2022;9:ofac067. (Among 160 patients enrolled in a long-term extension study of long acting cabotegravir and rilpivirine injections, adverse events included injection site reactions, headaches, nausea, depression, and vivid dreams and serious adverse events were uncommon, one patient developing “increased liver function test”).
Nachega JB, Scarsi KK, Gandhi M, Scott RK, Mofenson LM, Archary M, Nachman S, et al. (2023). Long-acting antiretrovirals and HIV treatment adherence. Lancet HIV. (Review of the availability, efficacy, safety, advantages and disadvantages of long-acting antivirals used for therapy and prevention of HIV including cabotegravir and rilpivirine; no mention of ALT elevations or hepatotoxicity).
Overton ET, Richmond G, Rizzardini G, Thalme A, Girard PM, Wong A, Porteiro N, et al. (2023). Long-acting cabotegravir and rilpivirine dosed every 2 months in adults with human immunodeficiency virus 1 type 1 infection: 152-week results from ATLAS-2M, a randomized, open-label, phase 3b, noninferiority study. Clin Infect Dis. (Among 1054 adults with HIV infection treated with injections of long acting cabotegravir and rilpivirine for up to three years, maintenance of HIV RNA suppression to less than 50 copies/mL was similar with every 4- vs 8-weekly administration [86% vs 87% at 3 years] with similar adverse event rates, ALT elevations above 3 times ULN arose in 6 subjects, 4 transiently and 2 requiring discontinuation of therapy - one being due to pancreatic cancer and one to chronic hepatitis C and alcohol abuse).

## OTHER REFERENCE LINKS

1 Recent References on Cabotegravir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Cabotegravir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Cabotegravir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cabotegravir)